# Maralixibat

## OVERVIEW

### Introduction

Maralixibat is an orally available inhibitor of the ileal bile salt transporter which is used to treat severe pruritus in patients with cholestatic liver disease including Alagille syndrome and progressive familial intrahepatic cholestasis (PFIC). Maralixibat is associated with transient serum enzyme fluctuations particularly with long term therapy which may be accompanied by worsening of the underlying chronic liver disease, but it has not been linked to instances of acute clinically apparent liver injury with jaundice, although experience with its use has been limited.

### Background

Maralixibat (mar" a lix' i bat) is an small molecule inhibitor of the ileal bile acid transporter that is used to treat pruritus in patients with cholestatic liver disease such as Alagille syndrome, a severe inherited disease marked by cholestatic liver injury and severe itching. The ileal bile acid transporter is responsible for the uptake of bile salts from the terminal ileum, an essential step in the entero-hepatic circulation of bile acids. Interruption of this enterohepatic circulation results in a decrease in serum bile acid levels and decline in the whole body bile acid pool, both of which are increased in patients with cholestatic liver disease and are associated with the symptom of pruritus. In animal models of cholestatic liver disease, administration of maralixibat resulted in marked decreases in serum bile acid levels, improvements in liver histology, and decrease in resultant hepatic fibrosis. In small open-label clinical trials in children with Alagille syndrome without cirrhosis, maralixibat resulted in improvements in bile acid levels, symptoms of pruritus, sleep disturbance and general well being. These improvements were maintained with long term treatment. Maralixibat was approved for use in patients with Alagille syndrome and severe pruritus in 2021. In 2024, indications were expanded to include patients with progressive familial intrahepatic cholestasis (PFIC), a similar, severe cholestatic disease of children. Maralixibat continues to be evaluated for efficacy and safety in other cholestatic liver diseases. Maralixibat is administered orally, acts locally on the ileal bile acid transporter, and has little systemic absorption. Maralixibat is available as a solution of 9.5 mg/mL for therapy of Alagille syndrome and as a solution of 19 mg/mL for PFIC under the brand name Livmarli. The recommended starting dose for Alagille syndrome is 190 µg/kg once daily, which can be increased to 380 µg/kg daily after a week, based upon tolerance. The starting dose for PFIC is 285 μg/kg once daily which can be progressively increased to as high as 570 μg/kg twice daily based upon efficacy and tolerance. Maralixibat is also available as tablets of 10, 15, 20, and 30 mg for older children who are able to swallow tablets. Adverse events include diarrhea, nausea and vomiting, bloating, abdominal pain, and elevations in serum aminotransferase levels, particularly with prolonged therapy and higher doses. Prolonged therapy can result in deficiencies in fat soluble vitamins, levels of which should be monitored during therapy. Severe adverse events are uncommon but can include gastrointestinal bleeding and bone fractures. Most of these side effects including fluctuations in liver tests also occur in patients with Alagille syndrome or PFIC who are not treated with ileal bile salt transporter inhibitors, and the role of maralixibat in causing symptoms and laboratory abnormalities is not always clear.

### Hepatotoxicity

In trials of maralixibat in children with Alagille syndrome, serum ALT levels rose to greater than 3 times the upper limit of normal (ULN) in 24% of patients and above 5 times ULN in 2%. The ALT elevations led to dose modification, interruption or therapy or early discontinuation in up to 10% of patients. In trials of maralixibat in children with PFIC, at least 4 cases of suspected drug-induced liver injury were reported by the FDA, one of which led to emergent liver transplantation. Children with Alagille syndrome and PFIC typically have serum aminotransferase elevations in the range of 2 to 5 times the upper limit of normal (ULN), and it is can be difficult to distinguish between spontaneous fluctuations in enzyme levels due to the underlying disease vs effects of maralixibat therapy. In many instances, therapy can be continued despite the serum enzyme elevations, at least at a reduced dosage. While there have been reports of worsening liver disease and hepatic decompensation in patients receiving maralixibat, the role of therapy in causing these complications is not always clear. There have been no published reports of acute, clinically apparent liver injury with jaundice attributed to maralixibat therapy, but it has had limited general clinical use.

Likelihood score: C (probable uncommon cause of worsening of liver injury in patients with chronic cholestatic liver disease).

### Mechanism of Injury

The mechanism by which maralixibat might cause liver injury is not known. It has minimal intestinal absorption and is unlikely to have a direct toxic effect on the liver. The serum aminotransferase elevations that occur with therapy may be due to its effects on absorption of fat soluble vitamins, nutrients or medications, or to fluxes in the bile acid pool, or to changes in the intestinal microbiome caused by alterations in intestinal bile acids.

### Outcome and Management

While chronic therapy with maralixibat can be associated with mild-to-moderate serum aminotransferase elevations, it has not been linked to any cases of acute, clinically apparent liver injury. Because of the frequency of enzyme elevations detected during therapy, the product label for maralixibat recommends obtaining baseline liver tests before initiation of treatment. Any subsequent rise in ALT or AST values associated with symptoms or jaundice should lead to prompt discontinuation of maralixibat. Patients with persistent elevations above 3 times ULN without symptoms or jaundice should be assessed for other causes of liver injury. If no other cause of the elevations is found, the dose of maralixibat should be reduced or therapy interrupted. There is no known cross sensitivity of the hepatic injury from maralixibat with other agents used to treat pruritus. Because of the similarity in chemical structure and mechanism of action, there may be cross sensitivity to side effects with odevixibat and linerixibat, other FDA approved ileal bile acid transporter inhibitors.

Drug Class: Ileal Bile Acid Transporter (IBAT) Inhibitors

Other Drugs in the Subclass, Pruritus Agents: Odevixibat, Linerixibat

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Maralixibat – Livmarli®

DRUG CLASS

Ileal Bile Acid Transporter (IBAT) Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Maralixibat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Maralixibat | 716313-53-0 | C40-H56-N3-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 01-April-2026

Abbreviations: ULN, upper limit of normal; PFIC, progressive familial intrahepatic cholestasis; PBC, primary biliary cholangitis; BSEP, bile salt export protein; FIC-1, familial intrahepatic cholestasis protein-1.

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 697-8. (Expert review of hepatotoxicity published in 1999 before the availability of inhibitors of the ileal bile acid transporter).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013, does not discuss maralixibat, odevixibat, or linerixibat).
Fuchs CD, Halilbasic E, Trauner M. Pathophysiologic basis of alternative therapies for cholestasis. In, Arias IM, Alter HJ, Boyer JL, Cohen DE, Shafritz DA, Thorgeirsson SS, Wolkoff AW. The Liver: biology and pathobiology. 6th ed. Hoboken, NJ: Wiley Blackwell, 2020, pp 364-77. (Textbook of liver physiology and disease).
FDA Medical Review of NDA for Maralixibat: Pages 79-86. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214662Orig1s000IntegratedR.pdf (FDA website with an integrated review of the efficacy and safety of maralixibat; mentions that during a placebo-control phase of an open-label maralixibat followed by a withdrawal study in 31 children with Alagille syndrome, almost all children had ALT elevations of 1 to 5 times ULN, but discontinuation of maralixibat was needed in 3 children for elevations in bilirubin [41.9 mg/dL] or ALT [598 and 815 U/L]).
Tiessen RG, Kennedy CA, Keller BT, Levin N, Acevedo L, Gedulin B, van Vliet AA, et al. Safety, tolerability and pharmacodynamics of apical sodium-dependent bile acid transporter inhibition with volixibat in healthy adults and patients with type 2 diabetes mellitus: a randomised placebo-controlled trial. BMC Gastroenterol. 2018;18:3. (Among 11 patients with type 2 diabetes and 50 healthy volunteers treated with volixibat [n= 46 in dose of 0.5 to 10 mg] or placebo [n=15] daily for 28 days, there were no significant changes in serum glucose or lipid levels between the two groups and while there were “individual” changes from baseline in some laboratory tests, “no clinically relevant changes were seen” ). 29304731
Palmer M, Jennings L, Silberg DG, Bliss C, Martin P. A randomised, double-blind, placebo-controlled phase 1 study of the safety, tolerability and pharmacodynamics of volixibat in overweight and obese but otherwise healthy adults: implications for treatment of non-alcoholic steatohepatitis. BMC Pharmacol Toxicol. 2018;19:10. (Among 84 overweight or obese healthy volunteers treated with volixibat [20 to 80 mg daily] or placebo for 12 days, volixibat therapy was associated with a 4-fold increase in bile acid excretion, a 6-fold increase in serum C4, despite no or barely detectable volixibat in plasma, while side effects occurred in all drug recipients, usually mild to moderate diarrhea starting on day one, but 4 treated patients [and no controls] developed ALT levels above twice ULN, without symptoms or jaundice, and all resolving spontaneously). 29548345
Mayo MJ, Pockros PJ, Jones D, Bowlus CL, Levy C, Patanwala I, Bacon B, et al. A randomized, controlled, phase 2 study of maralixibat in the treatment of itching associated with primary biliary cholangitis. Hepatol Commun. 2019;3:365-381. (Among 66 patients with primary biliary cholangitis [PBC] and pruritus treated with maralixibat [10 or 20 mg] or placebo once daily for 13 weeks, pruritus scores decreased in all 3 groups only slightly more with maralixibat while side effects were more frequent particularly diarrhea and abdominal discomfort; no mention of ALT elevations during therapy). 30859149
Kamath BM, Spino C, McLain R, Magee JC, Fredericks EM, Setchell KD, Miethke A, et al.; Childhood Liver Disease Research Network (ChiLDReN). Unraveling the relationship between itching, scratch scales, and biomarkers in children with Alagille syndrome. Hepatol Commun. 2020;4:1012-1018. (Among 37 children with Alagille syndrome, instruments to measure pruritus [the symptom of itching vs the physical findings of scratching] correlated poorly with bile salt, bilirubin and GGT levels, but symptom of itching did correlate with some elements of quality of life including fatigue and sleep disturbance). 32626833
Karpen SJ, Kelly D, Mack C, Stein P. Ileal bile acid transporter inhibition as an anticholestatic therapeutic target in biliary atresia and other cholestatic disorders. Hepatol Int. 2020;14:677-689. (Review of the mechanism of action and rationale for use of ileal bile acid transporter inhibitors as therapy of cholestatic liver diseases in children, such as biliary atresia and Alagille syndrome). 32653991
Gonzales E, Hardikar W, Stormon M, Baker A, Hierro L, Gliwicz D, Lacaille F, et al. Efficacy and safety of maralixibat treatment in patients with Alagille syndrome and cholestatic pruritus (ICONIC): a randomised phase 2 study. Lancet. 2021;398:1581-1592. (Among 31 children with Alagille syndrome treated with maralixibat for up to 48 weeks, symptoms of pruritus and bile salt levels improved and therapy was well tolerated; subsequent long term therapy resulted in improvements in xanthomata, but was accompanied by intermittent increases in serum ALT levels, resulting in dose reduction in 2 and discontinuation in one child). 34755627
Kohut TJ, Gilbert MA, Loomes KM. Alagille syndrome: a focused review on clinical features, genetics, and treatment. Semin Liver Dis. 2021;41:525-537. (Review of the pathogenesis, clinical features, laboratory abnormalities, liver histology, management and therapy of Alagille syndrome, an autosomal dominant condition involving variants in the JAG1 and NOTCH2 genes with multiorgan expression and variable penetrance associated with cholestatic liver disease, heart, renal and skeletal abnormalities with short stature and frequent need for liver transplantation). 34215014
Shirley M. Maralixibat: first approval. Drugs. 2022;82:71-76. (Review of the history of development, mechanism of action, clinical efficacy, and safety of maralixibat shortly after its approval in the US for the pruritus of Alagille syndrome, mentions that adverse events include diarrhea [56%], abdominal pain [54%], vomiting [41%], fat-soluble vitamin deficiency [26%], and ALT or AST elevations [19%], while long term therapy was accompanied by ALT elevations above 3 times ULN in 24% and 5 times ULN in 2%, most of which resolved spontaneously or after discontinuation). 34813049
Loomes KM, Squires RH, Kelly D, Rajwal S, Soufi N, Lachaux A, Jankowska I, et al. Maralixibat for the treatment of PFIC: Long-term, IBAT inhibition in an open-label, Phase 2 study. Hepatol Commun. 2022;6:2379-2390. (Among 33 children with PFIC treated with maralixibat [266 μg/kg once or twice daily] for up to 240 weeks, marked serum bile acid reductions and improvement in transplant free survival occurred only in patients with non-truncating mutations in BSEP and not in those with truncating mutations or with FIC1 mutations). 35507739
Bowlus CL, Eksteen B, Cheung AC, Thorburn D, Moylan CA, Pockros PJ, Forman LM, et al. Safety, tolerability, and efficacy of maralixibat in adults with primary sclerosing cholangitis: Open-label pilot study. Hepatol Commun. 2023;7:e0153. (Among 27 adults with sclerosing cholangitis treated with maralixibat for 14 weeks, itch scores decreased as did serum bile acid levels [by 17%], while adverse events occurred in 82% including diarrhea in 52% and abdominal pain in 30%, and abnormal liver tests were present in 82% but were attributed to the underlying disease and not the therapy). 37184523
Miethke AG, Moukarzel A, Porta G, Covarrubias Esquer J, Czubkowski P, Ordonez F, Mosca A, et al. Maralixibat in progressive familial intrahepatic cholestasis (MARCH-PFIC): a multicentre, randomised, double-blind, placebo- controlled, phase 3 trial. Lancet Gastroenterol Hepatol. 2024;9:620-631. (Among 93 children with PFIC treated with maralixibat or placebo for 26 weeks, there was improvement in pruritus scores and marked declines in serum bile acid levels with maralixibat in all forms of PFIC, while the adverse events more frequent with drug therapy included diarrhea [57% vs 20%], abdominal pain [26% vs 13%], and ALT increases [13% vs 7%] all of which were transient and without accompanying increases in bilirubin). 38723644

## OTHER REFERENCE LINKS

1. Recent References on Maralixibat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Maralixibat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Maralixibat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Maralixibat)